# Vilazodone

## OVERVIEW

### Introduction

Vilazodone is a selective serotonin reuptake inhibitor (SSRI) and partial serotonin receptor agonist which is used in the therapy of major depressive disorders. In premarketing clinical trials, vilazodone therapy was not associated with an increased rate of elevations in serum aminotransferase levels, and it has yet to be linked to instances of clinically apparent acute liver injury.

### Background

Vilazodone (vil az' oh done) is an SSRI that acts by blocking the reuptake of serotonin in CNS synaptic clefts, thus increasing serotonin levels in the brain which is associated with its psychiatric effects. Vilazodone is also a partial serotonin (5-HT1A) receptor agonist, which may add to its antidepressant effects. Vilazodone was approved for use in the United States in 2011 for use in treatment of major depressive disorder. There is limited clinical experience with its use. Vilazodone is available as tablets of 10, 20 and 40 mg under the brand name Viibryd. The recommended initial dose of vilazodone in adults is 10 mg daily, which can then be increased to the typical maintenance dose of 40 mg once daily. Common, non-serious side effects include diarrhea, nausea, fatigue, drowsiness, headache, insomnia, weight gain and sexual dysfunction. Overdose is associated with acute serotonin syndrome. Rare, but potentially severe adverse effects include suicidal thinking and behavior, activation of symptoms of mania, serotonin syndrome, sexual dysfunction, hyponatremia and hypersensitivity reactions.

### Hepatotoxicity

In premarketing studies, liver test abnormalities were uncommon in patients taking vilazodone (<1%) and no more frequent than in placebo recipients. No instances of acute, clinically apparent liver injury attributed to vilazodone have been reported. However, vilazodone has been in use for a short period of time. Most other SSRIs in clinical use have been associated with rare instances of acute liver injury, usually arising within 2 to 8 weeks of starting therapy. The pattern of serum enzyme elevations varied from hepatocellular to cholestatic. Autoimmune markers are not common, but immunoallergic features (rash, fever, eosinophilia) are frequent but usually not prominent. Most cases of acute liver injury due to SSRIs are mild-to-moderate in severity and resolve within one to three months. Acute liver failure due to the SSRIs has been described, but is very rare. No such cases have been linked to vilazodone use.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which vilazodone might cause liver injury is not known. Vilazodone is metabolized in the liver at least in part through cytochrome P450 pathways, predominantly CYP 3A4. It is susceptible to significant drug-drug interactions with increased serum levels when given with strong CYP 3A4 inhibitors (such as ketoconazole) and with reduced concentrations when given with strong inducers (such as carbamazepine).

### Outcome and Management

The serum aminotransferase elevations that occur on amoxapine therapy are usually self-limited and do not require dose modification or discontinuation of therapy. No instances of acute liver failure or vanishing bile duct syndrome due to amoxapine have been reported. There is no information on cross sensitivity to liver injury between amoxapine and other tricyclic antidepressants, but switching to another class of agents (such as the selective serotonin reuptake inhibitors) is probably prudent.

Drug Class: Antidepressant Agents

Other Drugs in the Subclass, SNRIs/SSRIs: Citalopram, Escitalopram, Duloxetine, Fluoxetine, Fluvoxamine, Levomilnacipran, Paroxetine, Sertraline, Venlafaxine, Vortioxetine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vilazodone – Viibryd®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Vilazodone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Vilazodone | 163521-08-2 | C26-H27-N5-O2.Cl-H

## ANNOTATED BIBLIOGRAPHY

References updated: 08 April 2020

Abbreviations: MAO inhibitor, monoamine oxidase inhibitor; SSRI, selective serotonin reuptake inhibitor; SNRI, serotonin and norepinephrine reuptake inhibitor.

Zimmerman HJ. Antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity published in 1999; before the availability of vilazodone).
Larrey D. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 507-26. (Review of hepatotoxicity of antidepressants published in 2007; clinically apparent liver injury from the SSRIs is rare, but probably underreported. "The clinical picture is variable, acute hepatocellular hepatitis appearing to be the most frequent event." No mention of vilazodone).
O'Donnell JM, Bies RR, Shelton RC. Drug therapy of depression and anxiety disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 267-77. (Textbook of pharmacology and therapeutics).
Mourilhe P, Stokes PE. (1998). Risks and benefits of selective serotonin reuptake inhibitors in the treatment of depression. Drug Saf. (Review of pharmacology, efficacy and safety of SSRIs; no mention of ALT elevations or hepatotoxicity or of vilazodone).
Lucena MI, Carvajal A, Andrade RJ, Velasco A. (2003). Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf. (Review of hepatotoxicity of antidepressants; antidepressant use has increased markedly between 1992 and 2002, accounting for 5% of cases of hepatotoxicity; SSRIs are less likely to cause injury than tricyclics and MAO inhibitors; range of presentations, typically self-limited and rapid recovery; no hallmarks of hypersensitivity; no mention of vilazodone).
Spigset O, Hä S, Bate A. (2003). Hepatic injury and pancreatitis during treatment with serotonin reuptake inhibitors: data from the World Health Organization (WHO) database of adverse drug reactions. Int Clin Psychopharmacol. (Among 27,542 reports of hepatic injury in WHO database, 786 were related to SSRIs [3%], including citalopram 42, fluoxetine 222, fluvoxamine 54, paroxetine 191, sertraline 112, nefazodone 91 and venlafaxine 74; only nefazodone has an excess of hepatic reports in relationship to total reports; no mention of vilazodone).
Degner D, Grohmann R, Kropp S. (2004). RüE, Bender S, Engel RR, Schmidt LG. Severe adverse drug reactions of antidepressants: results of the German multicenter drug surveillance program AMSP. Pharmacopsychiatry. (Analysis of adverse drug reactions reported from 1993-2000 in 35 psychiatric hospitals; 0.7% of SSRI recipients had a severe adverse event, hepatic in 0.05%).
Pinzani V, Peyriere H, Hillaire-Buys D, Pageaux GP, Blayac BP, Larrey D. (2006). Specific serotonin recapture inhibitor (SSRI) antidepressants: hepatotoxicity assessment in a large cohort in France. J Hepatol. (Abstract: Analysis of French Pharmacovigilance data on SSRIs found 63 cases of hepatotoxicity from paroxetine, 45 fluoxetine, 30 citalopram, 18 sertraline, and 2 fluvoxamine; vilazodone not mentioned).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were linked to any of the SSRIs).
Laughren TP, Gobburu J, Temple RJ, Unger EF, Bhattaram A, Dinh PV, Fossom L, et al. (2011). Vilazodone: clinical basis for the US Food and Drug Administration's approval of a new antidepressant. J Clin Psychiatry. (FDA analysis of data on safety and efficacy of vilazodone that led to its approval; 2989 subjects were exposed to vilazodone in 32 trials; common side effects were diarrhea [28%], nausea [23%], vomiting [5%], insomnia [6%], palpitations, fatigue and sexual dysfunction; overdose was associated with acute serotonin syndrome; "vilazodone was not associated with any clear finding of drug related changes in laboratory parameters, vital signs or weight").
(2011). Vilazodone (Viibryd)--a new antidepressant. Med Lett Drugs Ther. (Concise review of mechanism of action, efficacy, safety and cost of vilazodone shortly after its approval in the US mentions that common side effects are diarrhea and nausea and occasionally insomnia, dizziness, headache, weight gain and rarely sexual dysfunction; no mention of ALT elevations or hepatotoxicity).
Liebowitz M, Croft HA, Kajdasz DK, Whalen H, Gallipoli S, Athanasiou M, Reed CR. (2011). The safety and tolerability profile of vilazodone, a novel antidepressant for the treatment of major depressive disorder. Psychopharmacol Bull. (Among 1485 patients with major depression enrolled in two controlled trials of vilazodone, diarrhea, nausea and insomnia were the most frequent adverse events and there were no serum ALT elevations above 3 times ULN or serious hepatic adverse events).
Choi E, Zmarlicka M, Ehret MJ. (2012). Vilazodone: a novel antidepressant. Am J Health Syst Pharm. (Review of the structure, mechanism of action, pharmacology, efficacy and safety of vilazodone; in three clinical trials, ALT elevations were not mentioned or said to be no more frequent with vilazodone than placebo).
Citrome L. (2012). Vilazodone for major depressive disorder: a systematic review of the efficacy and safety profile for this newly approved antidepressant - what is the number needed to treat, number needed to harm and likelihood to be helped or harmed?. Int J Clin Pract. (Systematic review of safety and efficacy of vilazodone in depression; "Vilazodone was not associated with any clinically important changes in laboratory test parameters in serum chemistry, including liver function tests").
Robinson DS, Kajdasz DK, Gallipoli S, Whalen H, Wamil A, Reed CR. (2011). A 1-year, open-label study assessing the safety and tolerability of vilazodone in patients with major depressive disorder. J Clin Psychopharmacol. (Among 616 patients with depression enrolled in a 52 week open label study of vilazodone, common side effects were diarrhea and nausea, 21% of patients stopped therapy because of adverse events, and only 2 patients [0.4%] developed ALT elevations greater than 3 times ULN; no cases of clinically apparent liver injury were reported).
Iranikhah M, Wensel TM, Thomason AR. (2012). Vilazodone for the treatment of major depressive disorder. Pharmacotherapy. (Review of the mechanism of action, pharmacokinetics, efficacy and safety of vilazodone, based largely on premarketing trials; ALT elevations and liver injury were not mentioned).
Park SH, Ishino R. (2013). Liver injury associated with antidepressants. Curr Drug Saf. (Review of drug induced liver injury due to antidepressants including SSRIs, does not discuss vilazodone).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, one of which was attributed to venlafaxine, but none to other SSRIs or vilazodone).
Voican CS, Corruble E, Naveau S, Perlemuter G. (2014). Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry. (Review of the frequency and clinical features of drug induced liver injury due to antidepressants; several SSRIs are discussed [sertraline, paroxetine, fluoxetine, citalopram, fluvoxamine], but not vilazodone).
Croft HA, Pomara N, Gommoll C, Chen D, Nunez R, Mathews M. (2014). Efficacy and safety of vilazodone in major depressive disorder: a randomized, double-blind, placebo-controlled trial. J Clin Psychiatry. (Among 505 patients with major depression treated with vilazodone [40 mg/day] or placebo for 8 weeks, common side effects were nausea, diarrhea, dizziness and insomnia and changes in liver enzymes during therapy were mild and similar between groups, no patient developing both jaundice and hepatocellular enzyme elevations [>3 times ULN]).
Gommoll C, Durgam S, Mathews M, Forero G, Nunez R, Tang X, Thase ME. (2015). A double-blind, randomized, placebo-controlled, fixed-dose phase iii study of vilazodone in patients with generalized anxiety disorder. Depress Anxiety. (Among 680 patients with generalized anxiety disorder treated with vilazodone [20 or 40 mg/day] or placebo for 8 weeks, common side effects were nausea, diarrhea, dizziness and fatigue and changes in liver enzymes during therapy were similar in all groups, no patient developing both jaundice and hepatocellular enzyme elevations [>3 times ULN]).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases were attributed to antidepressants including 5 to SSRIs [fluoxetine, escitalopram, sertraline], but none to vilazodone).
Gommoll C, Durgam S, Mathews M, Forero G, Nunez R, Tang X, Thase ME. (2015). A double-blind, randomized, placebo-controlled, fixed-dose phase III study of vilazodone in patients with generalized anxiety disorder. Depress Anxiety. (Among 680 patients with generalized anxiety disorder treated with vilazodone [20 or 40 mg] or placebo once daily for 8 weeks, adverse events associated with vilazodone included nausea, vomiting, diarrhea, dizziness and fatigue, and changes in laboratory values were “generally small and similar among groups” and there were no instances of clinically apparent liver injury).
Mathews M, Gommoll C, Chen D, Nunez R, Khan A. (2015). Efficacy and safety of vilazodone 20 and 40 mg in major depressive disorder: a randomized, double-blind, placebo-controlled trial. Int Clin Psychopharmacol. (Among 1133 patients with major depression treated with vilazodone [20 or 40 mg], citalopram [40 mg] or placebo for 10 weeks, clinical improvements in depression scores were similar in the 3 treatment arms and greater than with placebo; while adverse events more frequent with vilazodone were diarrhea [26%], nausea [21-24%], and insomnia [6-7%] and rates of laboratory test abnormalities” were low and similar across treatment groups” and there were no cases of clinically apparent liver injury).
Baldwin DS, Chrones L, Florea I, Nielsen R, Nomikos GG, Palo W, Reines E. (2016). The safety and tolerability of vortioxetine: Analysis of data from randomized placebo-controlled trials and open-label extension studies. J Psychopharmacol. (Pooled analysis of 11 controlled trials and 5 extension studies of vortioxetine in 5701 patients major depression found the most common adverse events was nausea [21-31%] and that it had “no effect relative to placebo on clinical laboratory parameters”).
Voican CS, Martin S, Verstuyft C, Corruble E, Perlemuter G, Colle R. (2016). Liver function test abnormalities in depressed patients treated with antidepressants: a real-world systematic observational study in psychiatric settings. PLoS One. (Among 321 psychiatric inpatients, only 116 [36%] had liver tests performed and only 18 during therapy with an antidepressant, 3 of which were suspected to have drug induced liver injury, 1 each with escitalopram, venlafaxine and amitriptyline, all without jaundice and 2 without symptoms, all 3 resolving).
Friedrich ME, Akimova E, Huf W, Konstantinidis A, Papageorgiou K, Winkler D, Toto S, et al. (2016). Drug-induced liver injury during antidepressant treatment: results of AMSP, a drug surveillance program. Int J Neuropsychopharmacol. (Among 184,234 psychiatric inpatients from 80 hospitals, 149 cases [0.08%] of drug induced liver injury were reported including 22 of 70,060 [0.03%] receiving SSRIs, 71 of 50,201 [0.14%] patients treated with tricyclics and 3 of 3869 receiving MAO inhibitors [0.08%]).
Chen VC, Lin CF, Hsieh YH, Liang HY, Huang KY, Chiu WC, Lee Y, McIntyre RS, et al. (2017). Hepatocellular carcinoma and antidepressants: a nationwide population-based study. Oncotarget. (Among almost 50,000 cases of hepatocellular carcinoma registered in the Taiwan National Health Insurance Research Database, the rate of antidepressant use was lower than in approximately 250,000 matched controls from the database).
Ferrajolo C, Scavone C, Donati M, Bortolami O, Stoppa G, Motola D, Vannacci A, et al., DILI-IT Study Group. (2018). Antidepressant-induced acute liver injury: a case-control study in an Italian inpatient population. Drug Saf. (Among 179 cases of hospitalizations for unexplained acute liver injury enrolled in an Italian prospective study between 2010 and 2014, 17 had been exposed to antidepressants the major implicated agents being citalopram [n=4], sertraline [n=3], paroxetine [n=3], tricyclics [n=2], trazodone [n=1], fluoxetine [n=1], and duloxetine [n=1]; vilazodone not mentioned).
Billioti de Gage S, Collin C, Le-Tri T, Pariente A, Bégaud B, Verdoux H, Dray-Spira R, et al. (2018). Antidepressants and hepatotoxicity: a cohort study among 5 million individuals registered in the French National Health Insurance Database. CNS Drugs. (Among 5 million persons identified in a national French health insurance database who started an antidepressant between 2010 and 2015, 382 developed serious liver injury resulting in hospitalization, rates per 100,0000 persons-years being 19 for SSRIs, 22 venlafaxine, 13 duloxetine, and 33 mirtazapine).
Durgam S, Chen C, Migliore R, Prakash C, Edwards J, Findling RL. (2018). A phase 3, double-blind, randomized, placebo-controlled study of vilazodone in adolescents with major depressive disorder. Paediatr Drugs. (Among 400 patients with generalized anxiety disorder treated with vilazodone or placebo for 8 weeks, there were no differences between groups in serum enzyme elevations and no instances of clinically apparent liver injury).
Nishimura A, Aritomi Y, Sasai K, Kitagawa T, Mahableshwarkar AR. (2018). Randomized, double-blind, placebo-controlled 8-week trial of the efficacy, safety, and tolerability of 5, 10, and 20 mg/day vortioxetine in adults with major depressive disorder. Psychiatry Clin Neurosci. (Among 600 Japanese patients with major depression treated with vortioxetine [5, 10 or 20 mg] or placebo daily for 8 weeks, response rates were not significantly higher in the treated arms and side effects more common with vortioxetine included nausea, dizziness and insomnia; one patient discontinued therapy early because of abnormal liver tests, but details not provided).
Chan HL, Chiu WC, Chen VC, Huang KY, Wang TN, Lee Y, McIntyre RS, et al. (2018). SSRIs associated with decreased risk of hepatocellular carcinoma: A population-based case-control study. Psychooncology. (Analysis of the Taiwan National Health Service Insurance Research Database identified 59,859 patients with initial diagnosis of hepatocellular carcinoma and 285,124 matched controls; SSRI use was more frequent in the controls than in the HCC cases but only in analyses adjusted for possibly confounding factors).
Lochmann D, Richardson T. (2019). Selective serotonin reuptake inhibitors. Handb Exp Pharmacol. (Overview of the SSRIs mentioned that they have similar efficacy in treating depression and similar rates and adverse event profile which largely represents the effects of serotonin excess: nausea, diarrhea, dizziness, somnolence, insomnia, sweating, tremor anxiety, dry mouth, anxiety and restlessness; they can also cause weigh gain and sex dysfunction as well as activate mania and cause withdrawn symptoms).
Schwasinger-Schmidt TE, Macaluso M. (2019). Other antidepressants. Handb Exp Pharmacol. (Review of mechanism of action, pharmacology, clinical efficacy and side effects of atypical antidepressants including vilazodone which is a SSRI with additional partial agonism of the serotonin receptor with no discussion of hepatic side effects).
Pladevall-Vila M, Pottegård A, Schink T, Reutfors J, Morros R, Poblador-Plou B, Timmer A, et al. (2019). Risk of acute liver injury in agomelatine and other antidepressant users in four European countries: a cohort and nested case-control study using automated health data sources. CNS Drugs. (Analysis of data sources from 4 European countries identified 3.2 million persons initiating antidepressant therapy among whom there was no increased risk for acute liver injury for agomelatine compared to citalopram, an SSRI with a low rate of hepatotoxicity).
(2019). Drugs for anxiety disorders. Med Lett Drugs Ther. (Concise review of drugs for anxiety including SSRIs, SNRIs and benzodiazepines including mechanism of action, clinical efficacy, safety and costs; does not mention ALT elevations or hepatotoxicity).
Ueberberg B, Frommberger U, Messer T, Zwanzger P, Kuhn J, Anghelescu I, Ackermann K, Assion HJ. (2020). Drug-induced liver injury (DILI) in patients with depression treated with antidepressants: a retrospective multicenter study. Pharmacopsychiatry. (Among 329 psychiatric inpatients with depression seen at 6 psychiatric centers in Germany, 17 [5%] had serum aminotransferase elevations but none had clinically apparent liver injury, most commonly implicated drugs included mirtazapine, agomelatine, citalopram and venlafaxine).

## OTHER REFERENCE LINKS

1 Recent References on Vilazodone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Vilazodone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Vilazodone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Vilazodone)